# Green Tea

## OVERVIEW

### Introduction

Green tea is a popular and commonly consumed drink and its extract is found in many herbal and dietary supplements (HDS). Green tea extract and, more rarely, ingestion of large amounts of green tea have been implicated in cases of clinically apparent acute liver injury, including instances of acute liver failure and either need for urgent liver transplantation or death.

### Background

Both green tea and black tea are produced from the leaves of the Chinese tea tree Camellia sinensis. Green tea, unlike black tea, is unfermented, which helps to preserve its antioxidant polyphenolic catechols. Green tea has long been believed to have health restoring properties and its ingredients to have antioxidant activity. For this reason, extracts of green tea have been used as an herbal medication alone and in combination with other herbals and dietary supplements which are purported to improve health, prevent cancer and heart disease, decrease serum lipid levels, promote weight loss, decrease periodontal disease and even treat clostridial diarrhea. Green tea extract (GTE) is listed in more than 100 over-the-counter herbal preparations, but is not approved for any specific medical indication and is not regulated in regards to efficacy and safety by the FDA. The multiple polyphenols in green tea are believed to be the active components responsible for its purported chemoprotective, antiproliferative and antioxidant properties. The mechanism by which green tea may have such effects has not been elucidated. Human clinical studies demonstrate that single doses of up to 1.6 grams of green tea extract are well tolerated. The maximum tolerated dose in humans is reported to be 9.9 grams per day; a dose equivalent to 24 cups of green tea. Side effects of high doses of green tea extract are usually mild and include headache, dizziness and nausea. The safety and tolerability of long term use of green tea extracts has not been well defined.

### Hepatotoxicity

Drinking green tea has not been associated with liver injury or serum aminotransferase elevations; indeed, cross sectional studies suggest that regular use of green tea is associated with lower serum ALT and AST values. Nevertheless, case series and a systematic review by the United States Pharmacopeia have raised the issue of the potential for GTE to cause hepatotoxicity. In a large prospective study of GTE in postmenopausal woman at risk for breast cancer, GTE was associated with ALT elevations in 6.7% of patients compared to 0.7% of controls. In these studies, clinically apparent liver injury was not observed, but the extract was quickly discontinued in patients with ALT elevations. Restarting GTE in a proportion of patients was followed by rapid recurrence of ALT elevations that resolved again with stopping.

The prevalence of green tea extract induced acute liver injury with symptoms or jaundice is not known, but is undoubtedly low in comparison to the wide scale use of these products. Nevertheless, more than 100 instances of clinically apparent liver injury attributed to GTE have been reported in the literature. Liver injury typically arises within 1 to 6 months of starting the product but longer and shorter latencies (particularly with reexposure) have been reported. The majority of cases present with an acute hepatitis-like syndrome and a markedly hepatocellular pattern of serum enzyme elevations. Most patients recover rapidly upon stopping the extract or HDS, although fatal instances of acute liver failure have been described. Biopsy findings show necrosis, inflammation, and eosinophils in a pattern resembling acute hepatitis. Immunoallergic and autoimmune features are usually absent or minimal. A small number of similar cases have also been described after drinking green tea “infusions” rather than taking oral preparations of extracts of green tea.

The most prominent regulatory action against green tea containing products concerned Exolise, a weight loss product which was withdrawn from Spain and France in 2003. Also, green tea is an ingredient in many over-the-counter weight loss agents with names such as Hydroxycut, Dexatrim, Slimquick, Slimcut Fat Burner, The Right Approach, Mega Green Tea and Green Tea Fat Burner, among others, which have been implicated in causing rare instances of clinically apparent acute liver injury.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

Preclinical and human data implicate the catechin component of green tea as the culprit of hepatotoxicity. Approximately 10% of the green tea extract is composed of catechins; of these, epigallocatechin-3-gallate (EGCG) is present in highest concentration. There is great variability in the concentration of green tea extract, EGCG and other components among marketed products, which may explain while some products have been implicated in hepatotoxicity. Exposure of rat hepatocytes to EGCG has been shown to induce mitochondrial toxicity and generation of reactive oxygen species. The close association of liver injury from green tea with the HLA allele B*35:01 suggests an immunologic etiology. This HLA association, the lack of clear cut dose dependency and the recurrence of injury on reexposure (with a shorter latency) indicates that the injury is idiosyncratic and not due to direct toxicity of the catechins. The pathogenesis of green tea associated liver injury is an area of current, active investigation.

### Outcome and Management

Given the wide spread consumption of green tea and its extract in various HDS, liver injury from green tea is rare. Patients who present with acute liver injury, particularly with a hepatocellular pattern without an obvious cause, should be asked about the use of HDS and green tea extract, and should be advised to stop all herbal medications. In those drinking green tea regularly, stopping all use is prudent. In typical cases, recovery is expected in one to two months. As in any case of drug induced liver injury, the presentation with or development of abnormal liver function, deep jaundice, abnormal mentation suggestive of encephalopathy, prolongation of the prothrombin time or elevation of the INR, and a depressed albumin, should prompt referral for liver transplantation. Patients who developed acute liver injury attributable to green tea extract should be cautioned about reexposure and avoidance of HDS that might include green tea.

Drug Class: Herbal and Dietary Supplements

## CASE REPORTS

### Case 1. 37 year old woman with acute hepatitis after using weight loss supplement.(1)

A 37 year old woman developed nausea, abdominal pain and jaundice 4 months after starting a weight loss supplement called The Right Approach Complex (Pharmanex, Provo, Utah), the major component of which was green tea extract (“TeGreen”). She denied a history of liver disease, alcohol use, and risk factors for viral hepatitis. On examination, she was jaundiced but had no fever or rash. Laboratory tests showed serum bilirubin of 11.7 mg/dL and marked elevations in serum aminotransferase levels (~20 times ULN), with minimal increases in alkaline phosphatase (Table). Tests for hepatitis A, B and C were negative as were autoantibodies, except for antinuclear antibody which was weakly positive (1:40, speckled pattern). Liver biopsy revealed marked interface necrosis and inflammation and mild lobular inflammation. Cholecystectomy and intraoperative cholangiography were performed. The patient began to improve rapidly and was discharged after two weeks in the hospital. One month later, liver tests had improved significantly. One year later, she was again admitted with a one week history of abdominal pain and jaundice. She admitted to resuming The Right Approach Complex one month earlier, but stopped taking it one week before presentation when she developed dysphagia. On admission, she was jaundiced. She again improved rapidly and six months later all liver tests were normal.

#### Key Points

Medication: | The Right Choice (383.3 mg C. sinensis extract per 3 capsules)
Pattern: | Hepatocellular
Severity: | 3+
Latency: | 4 months initially, 1 month on reexposure
Recovery: | 1 month
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | | Started The Right Approach (~1 gram of green tea extract daily)
4 months | 0 | 1788 | 1783 | 238 | 11.7 | Liver biopsy
5 months | ~1 month | 92 | 79 | | 1.9
Time After Restarting | Time After Stopping Again | Restarted The Right Approach 1 year later
4 weeks | 0 | 1131 | 977 | 165 | 11.7 | INR: 1.3
5 weeks | 1 week | 877 | 816 | 165 | 2.9
9 weeks | 5 weeks | 69 | 80 | | 1.2
7 months | 6 months | 25 | 27 | 85 | 1.0
Normal Values | | <40 | <40 | <114 | <1.2

#### Comment

This case demonstrates the typical acute viral hepatitis-like presentation of green tea hepatotoxicity with jaundice, accompanied by marked elevations in serum aminotransferase levels and minimal increases in alkaline phosphatase. Recurrence with a similar pattern of liver injury upon reexposure to the same product provided strong evidence for a causal association. Green tea extract was the major ingredient of the supplement and its other components have not been reported to cause liver injury (calcium, chromium, magnolia extract, epimedium extract, banaba leaf extract, β-sitosterol and vanadium). This patient was later found to harbor HLA-B*35:01.

### Case 2. 27 year old man with hepatitis attributed to Hydroxycut.(2)

A 27 year old man developed fatigue and jaundice 4 to 5 weeks after starting Hydroxycut (9 tablets per day) for weight loss. He denied previous liver disease, alcohol abuse, recent travel or risk factors for viral hepatitis. He denied taking any other medications or herbal preparations. Laboratory tests showed serum bilirubin of 7.8 mg/dL and marked elevations in serum aminotransferase levels (ALT 3131 U/L, AST 1808 U/L), with minimal increases in alkaline phosphatase (171 U/L) (Table). Liver tests worsened for a day and then rapidly improved.

#### Key Points

Medication: | Hydroxycut (1.8 grams C. sinensis extract per day)
Pattern: | Hepatocellular (R=54)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4-5 weeks
Recovery: | 1-2 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
| Started Hydroxycut (1.86 g green tea extract daily)
5 weeks | 0 | 3131 | 171 | 7.8 | Admission
| 2 days | 3962 | | | Peak values
9 weeks | 4 weeks | 304 | | 1.3
Normal Values | | <40 | <150 | <1.2

#### Comment

Green tea hepatotoxicity typically presents with jaundice and an acute viral hepatitis-like syndrome, and a markedly hepatocellular pattern of serum enzyme elevations and rapid improvement upon stopping. Hydroxycut contains high concentrations of green tea extract, although formulations frequently change. Because Hydroxycut, like many dietary supplements, is a brand of many products with many ingredients, it is difficult to implicate a specific ingredient of the product as the cause for liver injury. Other listed components of Hydroxycut included calcium, chromium, potassium, Garcinia cambogia, Gymnema sylvestre leaf extract, glucomannan, alpha-lipoic acid, willow bark extract, L-carnitine, caffeine, guarana extract, gelatin, silica and cellulose.

### Case 3. 41 year old woman with severe hepatitis after use of a green tea weight loss supplement.(3)

A 41 year old Hispanic woman in general good health developed fatigue, nausea and weight loss followed by jaundice 3 to 4 weeks after starting “Green Tea Fat Burner”, a commercial weight loss product labelled as having 20 ingredients, including green tea extract (400 mg per capsule) and caffeine (160 mg per capsule), recommended to be taken twice daily. She had a remote history of an acute hepatitis of unknown cause 8 years earlier and a previous cholecystectomy. She had no other medical illnesses or drug allergies, took no prescription medications or other over-the-counter products, did not drink alcohol, and had no known risk factors for viral hepatitis. After several days of symptoms she stopped the supplement and sought medical attention 10 days later. On presentation, she was jaundiced but had no fever, rash or signs of chronic liver disease. Her body mass index was 40.7 kg/m^2^. Blood testing showed a total bilirubin of 6.3 mg/dL, ALT 2325 U/L, AST 2548 U/L and alkaline phosphatase 197 U/L (R ratio=20.9: hepatocellular). Tests for hepatitis A, B, C and E were negative. Both ANA and AMA were negative, while SMA was weakly positive (1:20). The INR was 1.5. She was initially followed as an outpatient, but with worsening symptoms and liver tests she was admitted and treated with N-acetyl cysteamine (Table). An ultrasound and CT scan of the abdomen showed hepatomegaly, but no evidence of biliary obstruction. Serum bilirubin rose to 26.7 mg/dL and INR to 1.7. A liver biopsy showed severe acute hepatitis with bridging necrosis but no fibrosis. She was not treated with corticosteroids and improved slowly. Jaundice persisted for more than a month but then resolved and at follow up at 6 months, liver tests were normal except for mild alkaline phosphatase elevations.

#### Key Points

Medication: | Green Tea Fat Burner (800 mg)
Pattern: | Hepatocellular (R=20.9)
Severity: | 4+ (INR elevations)
Latency: | 3-4 weeks
Recovery: | 4-6 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | INR | Comments
0 | | Started Green Tea Fat Burner
3 weeks | | Symptoms of fatigue and nausea. Supplement stopped
5 weeks | 14 days | 2325 | 197 | 6.3 | 1.5
6 weeks | 22 days | 1802 | 144 | 18.3 | | Admitted
| 26 days | 1532 | 120 | 20.7 | 1.7
| 28 days | 1440 | 120 | 20.1 | 1.8 | Liver biopsy
8 weeks | 35 days | 996 | 143 | 23.8 | 1.7
| 41 days | 667 | 128 | 20.9 | 1.6 | Discharged
| 6 months | 24 | 161 | 0.3 | 1.1 | Normal
Normal Values | | < 60 | < 120 | < 1.2 | <1.2

#### Comment

This patient had a severe and prolonged hepatitis arising within a month of starting a popular commercial, multiingredient, weight loss product containing green tea extract. The estimated dose was 800 mg daily for 3 to 4 weeks. The liver injury was judged to be highly likely due to green tea extract. The ingredients of the product included multiple herbal extracts including green tea, Asian ginseng, beeswax, bilberry, blueberry, eleuthero, elderberry, Yerba mate, pomegranate and Schisandra chinensis. HLA typing showed homozygosity for HLA-B*35:01. Severity was scored as 4+ (jaundiced, INR >1.5). Chronicity was scored as possible or minimal based upon the alkaline phosphatase levels. The short latency and medical history of acute hepatitis of unknown cause in the past suggests a previous episode of green tea related liver injury, so that this episode may have represented recurrence on reexposure.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Green Tea – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/greentea)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Green Tea | ID: CJ12600000 | Herbal Mixture | Not Applicable

## CITED REFERENCES

1 Bonkovsky HL. (2006). Hepatotoxicity associated with supplements containing Chinese green tea (Camellia sinensis). Ann Intern Med.
2 Stevens T, Qadri A, Zein NN. (2005). Two patients with acute liver injury associated with use of the herbal weight-loss supplement Hydroxycut. Ann Intern Med.
3 Hoofnagle JH, Bonkovsky HL, Phillips EJ, Li YJ, Ahmad J, Barnhart H, Durazo F, et al.; Drug-Induced Liver Injury Network. HLA-B*35:01 and green tea induced liver injury. Hepatology 2020 Sep 5. Epub ahead of print. (Case 33)

## ANNOTATED BIBLIOGRAPHY

References updated: 20 November 2020

Abbreviations: EGCG, epigallocatechin-3-gallate; GTE, green tea extract.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; Chinese herbal medications are discussed, but not green tea extract specifically).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] mentions that there have been at least 58 case reports of liver injury attributed to green tea extracts, powdered leaves or infusions including one fatal case).
Green tea. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 414-22. (Compilation of short monographs on herbal medications and dietary supplements).
Imai K, Nakachi K. (1995). Cross-sectional study of effects of drinking green tea on cardiovascular and liver diseases. BMJ. (In a population based survey of 1371 Japanese men, drinking >10 cups of green tea daily was associated with lower total cholesterol and triglycerides levels, increased HDL and lower ALT [19 vs 24 U/L] and AST [23 vs 25 U/L] values).
Larrey D. (1997). Hepatotoxicity of herbal remedies. J Hepatol. (Review of hepatotoxicity of herbals focusing upon pyrrolizidine alkaloids, germander and Chinese herbal medications; green tea was not mentioned).
Gavilán JC, Bermúdez FJ, Salgado F, Peña D. (1999). Fitoterapia y hepatitis. Rev Clin Esp. (19 year old woman developed jaundice 14 weeks after starting herbal tea and 8 weeks after starting capsules of green tea [bilirubin 11 mg/dL, ALT 1110 U/L], with severe recurrence 3 years later within 3-4 weeks of restarting the capsules).
Stickel F, Egerer G, Seitz HK. (2000). Hepatotoxicity of botanicals. Public Health Nutr. (Review of hepatotoxicity of herbals focusing upon Chinese herbals, germander, pyrrolizidine alkaloids, chaparral; no mention of green tea extracts).
Seddik M, Lucidarme D, Creusy C, Filoche B. (2001). Gastroenterol Clin Biol. (50 year old woman developed jaundice 2 months after starting "Exolise", a green tea extract containing commercial herbal product [bilirubin 7.5 mg/dL, ALT 40 times ULN, Alk P 1.5 times ULN], resolving within 2 months of stopping).
Chantre P, Lairon D. (2002). Recent findings of green tea extract AR25(Exolise) and its activity for the treatment of obesity. Phytomedicine. (Green tea extract AR25 [Exolise] is an 80% ethanol extract of green tea standardized to 25% catechins, primarily epigallocatechin gallate and caffeine, but also others; it inhibits gastric and pancreatic lipase in vitro and stimulates thermogenesis; in an open label study, 70 obese patients lost an average of 4.6% of body weight over a 6 month period; serum ALT elevations occurred in one patient, but no details given).
Haller CA, Dyer JE, Ko R, Olson KR. (2002). Making a diagnosis of herbal-related toxic hepatitis. West J Med. (Two cases demonstrating the difficulties of identifying the toxic component of herbals: 42 year old woman developed fatigue 10 weeks after starting 3 herbal medications [bilirubin 1.2 mg/dL, ALT 3386 U/L, Alk P 100 U/L], ultimately attributed to Jin Bu Huan; 39 year old woman developed acute liver failure after taking multiple herbals [bilirubin 42.7 mg/dL, ALT 349 U/L, INR 3.9] believed to be due to chaparral).
Thiolet C, Mennecier D, Bredin C, Moulin O, Rimlinger H, Nizou C, Vergeau B, Farret O. (2002). Gastroenterol Clin Biol. (39 year old woman developed fatigue 4 months after starting biweekly “infusions of Oolong tea fine tonic” [ALT peak 45 times and Alk P 3.5 times ULN, bilirubin not given], resolving within 8 weeks of stopping).
Pedrós C, Cereza G, García N, Laporte JR. (2003). Med Clin(Barc). (4 reports of liver injury due to "Exolise" led to its withdrawal in Spain; women, ages 29 to 69 years, onset 15-45 days after starting herbal with hepatocellular injury [bilirubin 18-19 mg/L, ALT 4-40 times ULN, Alk P 1.5-2 times ULN], resolving in 3 subjects with follow up information).
Vial T, Bernard G, Lewden B, Dumortier J, Descotes J. (2003). Gastroenterol Clin Biol. (46 year old woman developed jaundice 12 weeks after starting "Exolise" [bilirubin 29.1 mg/dL, ALT 75 times and Alk P 2 times ULN], with rapid recovery and recurrence on reexposure).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being greater celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma Huang [3], pennyroyal [1], skullcap [2], Chinese herbs [9], valerian [1]; green tea not specifically listed or mentioned).
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. (2003). High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg. (Among 20 patients undergoing liver transplantation for acute liver failure at two US transplant centers during 2001-2, 10 were attributed to herbals, but none to green tea extract).
Lenz TL, Hamilton WR. Supplemental products used for weight loss. J Am Pharm Assoc (2003). 2004; 44(1): 59-67. (At least 50 herbal and dietary supplements have been promoted for weight loss, but none have strong clinical evidence of efficacy and several are toxic [ephedra and green tea]).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 7 [5%] for herbal medications, including 1 attributed to kava and 1 to chaparral tea; green tea was not specifically mentioned).
García-Morán S, Sáez-Royuela F, Gento E, López Morante A, Arias L. (2004). Gastroenterol Hepatol. (25 year old woman developed jaundice 2 months after starting green tea extract [bilirubin 19.9 mg/dL, ALT 2398 U/L, Alk P 164 U/L], resolving within 2 months of stopping).
Dueñas Sadornil C, Fabregas Puigtió S, Durández R. (2004). Hepatotoxicidad por Camelia sinensis. Med Clin (Barc). (35 year old woman developed jaundice 5 weeks after starting "Exolise" [18.9 mg/dL, ALT 1558 U/L, Alk P 430 U/L], resolving within 2 months of stopping; same case as Pedros [2003]).
Peyrin-Biroulet L, Petitpain N, Kalt P, Ancel D, Petit-Laurent F, Trechot P, Barraud H, Bronowicki JP. (2004). Gastroenterol Clin Biol. (50 year old woman developed jaundice 15 days after starting Minifit [epigallocatechin gallate], with bilirubin 4.7 mg/dL, ALT 54 times ULN, resolving within 2 months of stopping, patient had a similar event a year earlier).
Schmidt M, Schmitz HJ, Baumgart A, Guédon D, Netsch MI, Kreuter MH, Schmidlin CB, Schrenk D. (2005). Toxicity of green tea extracts and their constituents in rat hepatocytes in primary culture. Food Chem Toxicol. (Green tea extracts were toxic to isolated rat hepatocytes in vitro, the active toxic component being epigallocatechin gallate, the major catechin in green tea).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al., Spanish Group for the Study of Drug-Induced Liver Disease. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. (Reports of drug induced liver injury to a Spanish network found 570 cases, herbal medications accounted for 9 cases [~2%]).
Gloro R, Hourmand-Ollivier I, Mosquet B, Mosquet L, Rousselot P, Salamé E, Piquet MA, Dao T. (2005). Fulminant hepatitis during self-medication with hydroalcoholic extract of green tea. Eur J Gastroenterol Hepatol. (48 year old woman developed jaundice 2 months after starting Exolise [bilirubin 26.3 mg/dL, ALT 102 times ULN, Alk P normal, prothrombin index 12%], with progressive liver failure requiring transplantation).
Stevens T, Qadri A, Zein NN. (2005). Two patients with acute liver injury associated with use of the herbal weight-loss supplement Hydroxycut. Ann Intern Med. (27 and 30 year old men developed jaundice 2 and 5 weeks after starting a Hydroxycut product [bilirubin 7.8 and 7.8 mg/dL, ALT 3131 and 45 U/L, Alk P 171 and 530 U/L], resolving within 1-2 months of stopping: Case 2).
Porcel JM, Bielsa S, Madronero AB. Hepatotoxicity associated with green tea extracts. [Electronic letter]. Accessed by www.annals.org on June 3 2005. (53 year old woman developed jaundice 2 weeks after stopping a 2 week course of a GTE [bilirubin 5.3 mg/dL, ALT 927 U/L, Alk P 187 U/L], resolving in 5 weeks).
Abu el Wafa Y, Benavente Fernández A, Talavera Fabuel A, Pérez Ramos MA, Ramos-Clemente JI. (2005). Hepatits aguda inducida por Camellia sinensis (té verde). An Med Interna. (35 year old woman developed jaundice 10 days after starting "Exolise" for obesity [bilirubin 19.5 mg/dL, ALT 2885, Alk P 182 U/L], resolving within 2 months).
Bonkovsky HL. (2006). Hepatotoxicity associated with supplements containing Chinese green tea (Camellia sinensis). Ann Intern Med. (37 year old woman developed jaundice 4 months after starting “The Right Approach Complex” [which contains GTE] for weight loss [bilirubin 11.7 mg/dL, ALT 1788 U/L, Alk P 238 U/L], with resolution in 1 month of stopping and recurrence within 1 month of restarting the product: Case 1).
Martínez-Sierra C, Rendón Unceta P, Martín Herrera L. (2006). Hepatitis aguda tras ingestión de té verde. Med Clin (Barc). (26 year old woman developed jaundice 4 months after starting weekly green tea “infusions” [bilirubin 6.5 mg/dL, ALT 3314, Alk P not mentioned], with recurrence within 2 weeks of restarting the drink [bilirubin 19 mg/dL, ALT 1750, Alk P 240] and resolving in 2 months after stopping).
Galati G, Lin A, Sultan AM, O'Brien PJ. (2006). Cellular and in vivo hepatotoxicity caused by green tea phenolic acids and catechins. Free Radic Biol Med. (In vitro study of toxicity of green tea phenolic acids on rat hepatocytes, the most toxic component to mitochondrial membrane potential was epigallocatechin-3-gallate, which is the major component of green tea and is detoxified by glutathione).
Javaid A, Bonkovsky HL. (2006). Hepatotoxicity due to extracts of Chinese green tea (Camellia sinensis): a growing concern. J Hepatol. (Letter in response to editorial by Stickel [2005] describing a 46 year old woman who developed jaundice 7 months after starting green tea extracts [bilirubin 12.3 rising to 29.5 mg/dL, ALT 1100 U/L, Alk P 194 U/L]; scant information and no follow up provided).
Jimenez-Saenz M, Martinez-Sanchez M del C. (2006). Acute hepatitis associated with the use of green tea infusions. J Hepatol. (45 year old man drinking 6 cups of marketed green tea “infusions” daily for 4 months developed jaundice [bilirubin 7 mg/dL, ALT 1613 U/L, Alk P 310 U/L], resolving within 2 months of stopping and recurring within 1 month of restarting).
Molinari M, Watt KD, Kruszyna T, Nelson R, Walsh M, Huang WY, Nashan B, Peltekian K. (2006). Acute liver failure induced by green tea extracts: case report and review of the literature. Liver Transpl. (44 year old woman developed jaundice 4 months after starting GTE [720 mg/day] for weight loss [bilirubin 13.1 rising to 43.2 mg/dL, ALT 3583 U/L, GGT 112 U/L], undergoing liver transplantation 17 days after admission; patient was also on progesterone injections for contraception).
Jimenez-Saenz M, Martinez-Sanchez C. (2007). Green tea extracts and acute liver failure: the need for caution in their use and diagnostic assessment. Liver Transpl. (Letter in response to Molinari [2006] indicating that progesterone may have contributed to the injury and describing a 22 year old woman who developed jaundice 2 weeks after starting progesterone [bilirubin 13.5 mg/dL ALT 1584 U/L], with resolution on stopping).
Federico A, Tiso A, Loguercio C. (2007). A case of hepatotoxicity caused by green tea. Free Radic Biol Med. (51 year old woman was found to have abnormal liver enzymes during the 5 years that she drank green tea daily, which normalized when she stopped and became abnormal again when she restarted [ALT 4-5 times ULN, Alk P 1.5-2 times ULN]).
Björnsson E, Olsson R. (2007). Serious adverse liver reactions associated with herbal weight-loss supplements. J Hepatol. (5 cases of liver injury from green tea containing herbal [Cuur] reported to Swedish Adverse Drug Reactions Advisory Committee over 2 years; 4 women and 1 man, ages 35 to 64 years, taking product for 5-20 weeks, 4 with jaundice [bilirubin 1-25 times ULN, ALT 25-95 times ULN, Alk P 1.4-8.3 times ULN], all resolved within 5-12 weeks of stopping, 4 received prednisone).
Jones FJ, Andrews AH. (2007). Acute liver injury associated with the herbal supplement hydroxycut in a soldier deployed to Iraq. Am J Gastroenterol. (19 year old male US Army soldier in Iraq developed jaundice 4 months after starting a Hydroxycut weight loss product [bilirubin 11.7 mg/dL, ALT 1143 U/L, Alk P 153 U/L], resolving within 4 months of stopping).
Elinav E, Pinsker G, Safadi R, Pappo O, Bromberg M, Anis E, Keinan-Boker L, et al. (2007). Association between consumption of Herbalife nutritional supplements and acute hepatotoxicity. J Hepatol. (12 cases of hepatotoxicity attributed to Herbalife products in Israel, 11 women, 1 man, ages 32 to 78 years, onset after 2-35 months [mean peak bilirubin 9.1 mg/dL, ALT 1481 U/L, Alk P 282 U/L], 1 with ANA resolving on recovery; 11 patients recovered, one died of hepatitis B reactivation, 3 redeveloped liver injury upon reexposure).
Schoepfer AM, Engel A, Fattinger K, Marbet UA, Criblez D, Reichen J, Zimmermann A, Oneta CM. (2007). Herbal does not mean innocuous: ten cases of severe hepatotoxicity associated with dietary supplements from Herbalife products. J Hepatol. (10 cases of hepatotoxicity due to Herbalife products in Switzerland; 3 men and 7 women, ages 30 to 69 years, with onset after 2-144 months, 9 with jaundice [bilirubin 0.4-28.2 mg/dL, ALT 4-50 times ULN, Alk P 1.1-6.5 times ULN], 2 with recurrence on rechallenge, 3 requiring liver transplant, 1 with sinusoidal obstruction syndrome, 1 with cirrhosis).
Stickel F. (2007). Slimming at all costs: Herbalife-induced liver injury. J Hepatol. (Editorial in reference to Schoepfer [2007] and Elinay [2007] discussing the difficulties in assigning causality and identifying the toxic component in herbal products, many patients take multiple products and each may include multiple components and possibly contain contaminants).
Duque JM, Ferreiro J, Salgueiro E, Manso G. (2007). Med Clin(Barc). (3 cases of hepatotoxicity attributed to Herbalife products, women ages 49 to 54 years, with onset of liver injury after 1, 6 and 36 months [bilirubin 0.7, 0.8, and 26.6 mg/dL, ALT 138, 505 and 1890 U/L, Alk P 112, 166 and 425 U/L], resolving in all 3 upon stopping).
Chao S, Anders M, Turbay M, Olaiz E, Mc Cormack L, Mastai R. (2008). Acta Gastroenterol Latinoam. (63 year old woman developed jaundice and pruritus 2.5 months after starting Herbalife products [peak bilirubin 17.5 mg/dL, ALT 847 U/L, Alk P 3 times ULN], resolving within 5 months of stopping).
Manso G, López-Rivas L, Duque JM, Salgueiro E. (2008). Spanish reports of hepatotoxicity associated with Herbalife products. J Hepatol. (Discussion of 4 cases of Herbalife hepatotoxicity from Spain [3 reported by Duque 2007], 2 occurring in sisters, suggesting a genetic propensity and an idiosyncratic drug reaction).
Ignarro L, Heber D, Henig YS, Bejar E. (2008). Herbalife nutritional products and liver injury revisited. J Hepatol. (Comment on publications on Herbalife hepatotoxicity [Elinav and Schoepfer 2007] questioning whether their product was involved, as the product is used by millions).
Vanstraelen S, Rahier J, Geubel AP. (2008). Jaundice as a misadventure of a green tea (camellia sinensis) lover: a case report. Acta Gastroenterol Belg. (76 year old man who drank 6-7 “infusions” of green tea daily for years developed jaundice [bilirubin 16.7 mg/dL, ALT 646 U/L, Alk P 331 U/L], resolving within 10 weeks of stopping).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to a Spanish registry, 13 [2%] were due to herbals, 3 due to green tea extracts; 23-27 year olds developed jaundice 5, 19 and 121 days after starting green tea [bilirubin 11.4-16.6 mg/dL, ALT 6-84 times ULN, Alk P 0.9-1.6 times ULN], resolving within 1.5-3 months of stopping).
Sarma DN, Barrett ML, Chavez ML, Gardiner P, Ko R, Mahady GB, Marles RJ, et al. (2008). Safety of green tea extracts: a systematic review by the US Pharmacopeia. Drug Saf. (US Pharmacopoeia review of green tea hepatotoxicity identified 216 adverse event reports, including 34 of liver injury [8 published, others from Spanish, French, US, UK, Canadian and Australian safety reports], which were scored as probable in 7 and possible in 27; in most cases, there were multiple agents involved; the committee recommending taking green tea with meals).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, green tea being prominently incriminated).
Dara L, Hewett J, Lim JK. (2008). Hydroxycut hepatotoxicity: a case series and review of liver toxicity from herbal weight loss supplements. World J Gastroenterol. (Two women ages 33 and 40 years with onset of symptoms 1 and 4 weeks after starting a Hydroxycut weight loss product [bilirubin 0.7 and 20.9 mg/dL, ALT 1150 and 934 U/L, Alk P 299 and 112 U/L], resolving rapidly upon stopping; ingredients included green tea extract but not ephedra).
Lobb A. (2009). Hepatoxicity associated with weight-loss supplements: a case for better post-marketing surveillance. World J Gastroenterol. (Letter in response to Dara [2008] summarizing reports of liver injury attributed to Hydroxycut products and recommending more stringent regulations for HDS products in the United States).
Bergman J, Schjøtt J. (2009). Hepatitis caused by Lotus-f3?. Basic Clin Pharmacol Toxicol. (56 year old woman with psoriatic arthritis on etanercept developed jaundice 3 weeks after starting "Lotus-f3", a multiingredient product that contains GTE, for weight loss [bilirubin 17.5 mg/dL, ALT 1871 U/L, Alk P 342 U/L, INR 1.2], resolving within 6 weeks of stopping both agents and not recurring when etanercept was restarted).
McDonnell WM, Bhattacharya R, Halldorson JB. (2009). Fulminant hepatic failure after use of the herbal weight-loss supplement exilis. Ann Intern Med. (25 year old man developed jaundice several weeks after starting Exilis, a multiingredient product that contains GTE [bilirubin 10.5 mg/dL, ALT 2362 U/L, INR 1.9], with progressive hepatic failure and urgent liver transplant 5 days after admission).
Verhelst X, Burvenich P, Van Sassenbroeck D, Gabriel C, Lootens M, Baert D. (2009). Acute hepatitis after treatment for hair loss with oral green tea extracts (Camellia Sinensis). Acta Gastro-Enterologica Belgica. (41 year old woman developed jaundice 6 months after starting green tea containing herbal [bilirubin 13.6 mg/dL, ALT 2801 U/L, Alk P 251 U/L], with rapid resolution on stopping).
Shim M, Saab S. (2009). Severe hepatotoxicity due to Hydroxycut: a case report. Dig Dis Sci. (28 year old man developed jaundice 3 months after starting a Hydroxycut weight loss product containing green tea extract [bilirubin 18.1 mg/dL, ALT 2272 U/L, Alk P 152 U/L, ANA 1:40], with rapid improvement on stopping).
Schneider C, Segre T. (2009). Green tea: potential health benefits. Am Fam Physician. (Review of health benefits of green tea, the medical evidence for benefit being of limited quality and often inconsistent).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; specific discussion of green tea, Hydroxycut, Herbalife and traditional Chinese herbal medicines).
Mazzanti G, Menniti-Ippolito F, Moro PA, Cassetti F, Raschetti R, Santuccio C, Mastrangelo S. (2009). Hepatotoxicity from green tea: a review of the literature and two published cases. Eur J Clin Pharmacol. (Review of literature and addition of two cases from Italy; 81 year old woman developed jaundice 1 month after starting "Epinerve" which contained epigallocatechin gallate [bilirubin 21.8 mg/dL, ALT 2638 U/L], resolving within 3 months of stopping; and, 72 year old woman with jaundice 3 months after starting "Epinerve" [bilirubin 18 mg/dL; ALT >700 U/L], resolving rapidly on stopping).
Amariles P, Angulo N, Agudelo-Agudelo J, Gaviria G. (2009). Farm Hosp. (43 year old woman taking green tea infusions for constipation for 8 months developed nausea [bilirubin 2.1 mg/dL, ALT 841 U/L, Alk P 100 U/L], with rapid recovery upon stopping).
Lambert JD, Kennett MJ, Sang S, Reuhl KR, Ju J, Yang CS. (2010). Hepatotoxicity of high oral dose(-)-epigallocatechin-3-gallate in mice. Food Chem Toxicol. (In mice, high oral doses of epigallocatechin gallate cause ALT elevations and acute hepatic necrosis within 24-48 hours).
Sharma T, Wong L, Tsai N, Wong RD. (2010). Hydroxycut(®) (herbal weight loss supplement) induced hepatotoxicity: a case report and review of literature. Hawaii Med J. (19 year old man developed fever, rash, fatigue and then jaundice 1 week after starting a Hydroxycut weight loss product [bilirubin 7.3 mg/dL, ALT 81 U/L, Alk P 298 U/L, protime 16.7 sec], biopsy showed scant necrosis, recovery within 14 weeks of stopping).
Fong TL, Klontz KC, Canas-Coto A, Casper SJ, Durazo FA, Davern TJ, Hayashi P, et al. (2010). Hepatotoxicity due to hydroxycut: a case series. Am J Gastroenterol. (Details of 17 cases of hepatotoxicity due to Hydroxycut in the US between 2002-9; latency to onset ranged from 2-12 weeks with two outliers at 1 and 2 years, typical pattern of injury was hepatocellular, often severe, 4 were fatal or led to liver transplantation).
Rashid NN, Grant J. (2010). Hydroxycut hepatotoxicity. Med J Aust. (23 year old woman developed jaundice approximately 8 weeks after starting Hydroxycut [bilirubin 6.6 mg/dL, ALT 2950 U/L, Alk P 121 U/L], resolving within 4 weeks of stopping).
Stiefelhagen P. (2010). MMW Fortschr Med. (News report on liver injury due to nutritional supplements such as Herbalife products [at least 22 cases being reported between 1998 and 2004] and Hydroxycut products).
Jóhannsson M, Ormarsdóttir S, Olafsson S. (2010). Laeknabladid. (5 cases of liver injury attributed to Herbalife products from Iceland; 4 women and 1 man, ages 29 to 78 years with onset after 1-7 months of use [bilirubin 1.3-15.6 mg/dL, ALT 456-2637 U/L, Alk P 149-712 U/L], all recovered upon stopping).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut).
Harvey KJ. (2010). Hydroxycut hepatotoxicity. Med J Aust. (Letter in response to Rashid [2010] stating that Hydroxycut preparations in Australia continue to have the same ingredients that led to its withdrawal in the US, including green tea extract).
Chen GC, Ramanathan VS, Law D, Funchain P, Chen GC, French S, Shlopov B, et al. (2010). Acute liver injury induced by weight-loss herbal supplements. World J Hepatol. (Three women, ages 31, 37 and 53 years, taking Hydroxycut or Herbalife products for weight loss developed jaundice 3, 4 and 12 months after starting [bilirubin 15.3, 29.9, and 18.2 mg/dL, ALT 1227, 2068 and 983 U/L, Alk P 268, 185 and 292 U/L], resolving within 2-3 months of stopping).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids).
Yellapu RK, Mittal V, Grewal P, Fiel M, Schiano T. (2011). Acute liver failure caused by 'fat burners' and dietary supplements: a case report and literature review. Can J Gastroenterol. (28 year old woman developed jaundice one month after starting two "fat burners" [Somalyz and Lipolyz] containing usnic acid and green tea as an aid to body building [bilirubin 4.8 mg/dL, ALT 1220 U/L, Alk P 111 U/L, INR 2.6], with rapid progression to acute liver failure requiring liver transplantation; the explant showed massive necrosis).
Thavanesan N. (2011). The putative effects of green tea on body fat: an evaluation of the evidence and a review of the potential mechanisms. Br J Nutr. (Review of mechanisms of action of green tea in weight loss suggesting that multiple mechanisms are involved).
Appelhans K, Smith C, Bejar E, Henig YS. (2011). Revisiting acute liver injury associated with herbalife products. World J Hepatol. (Letter in response to Chen [2010] arguing that the two cases attributed to Herbalife products were inadequately documented).
Manso G, López-Rivas L, Salgueiro ME, Duque JM, Jimeno FJ, Andrade RJ, Lucena MI. (2011). Continuous reporting of new cases in Spain supports the relationship between Herbalife® products and liver injury. Pharmacoepidemiol Drug Saf. (Update on cases of liver injury reported to the Spanish Pharmacovigilance Database between 2003-2010 identified 20 cases of liver injury possibly due to Herbalife products; 16 in women, mean age 45 years, 12 hospitalized, [bilirubin 0.6 to 33.3 mg/dL, ALT 88 to 3269 U/L, Alk P 112 to 1034 U/L]; one patient developed cirrhosis, the others recovered; 1 to 9 different Herbalife products were implicated and no single ingredient appeared common to most cases).
Appelhans K, Frankos V, Shao A. (2012). Misconceptions regarding the association between Herbalife products and liver-related case reports in Spain. Pharmacoepidemiol Drug Saf. (Letter in response to Manso [2011] arguing that the causality process used was faulty and that application of WHO criteria would weaken the scoring of cases to conditional or only possibly related to the Herbalife products).
Rohde J, Jacobsen C, Kromann-Andersen H. (2011). Ugeskr Laeger. (Abstract: Description of patient with liver injury arising 6 months after starting ingestion of 4-6 cups of green tea daily).
Larrey D, Faure S. (2011). Herbal medicine hepatotoxicity: a new step with development of specific biomarkers. J Hepatol. (Editorial on the problem of hepatotoxicity of herbal medications, the difficulties of causality assessment, the variability of the products, possibly of contamination, lack of rigorous regulations and need for biomarkers for hepatic injury).
Appelhans K, Frankos V. (2012). Herbal medicine hepatotoxicity revisited. J Hepatol. (Letter in response to Larrey [2011] arguing that Herbalife products are carefully assessed for purity and that the green tea extracts used have never been implicated in causing liver injury; authors reply that idiosyncratic liver injury occurs with many medications of proven purity).
Weinstein DH, Twaddell WS, Raufman JP, Philosophe B, Mindikoglu AL. (2012). SlimQuick™ - associated hepatotoxicity in a woman with alpha-1 antitrypsin heterozygosity. World J Hepatol. (24 year old woman developed jaundice 3 months after starting "SlimQuick", a weight loss agent with multiple herbal ingredients including GTE with 135 mg of EGCG, [bilirubin 4.0 mg/dL, ALT 2615 U/L, Alk P 200 U/L], with little improvement 30 days after stopping herbal, but prompt recovery with prednisone therapy and no relapse on subsequent withdrawal).
Jiménez-Encarnación E, Ríos G, Muñoz-Mirabal A, Vilá LM. Euforia-induced acute hepatitis in a patient with scleroderma. BMJ Case Rep 2012; 2012. (45 year old woman with systemic sclerosis developed jaundice 1 month after starting "Euphoria", a combination herbal product whose ingredients included aloe vera, resveratrol, green tea, noni and several berries [bilirubin 17.7 mg/dL, ALT 837 U/L, Alk P 134 U/L], with slow recovery over the 18 months after stopping).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including 19 publications on green tea, 13 on Herbalife and 6 on Hydroxycut products).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury mentions that green tea has been associated with clinically apparent hepatotoxicity).
Appelhans K, Najeeullah R, Frankos V. (2013). Letter: retrospective reviews of liver-related case reports allegedly associated with Herbalife present insufficient and inaccurate data. Aliment Pharmacol Ther. (Letter in response to Bunchorntavakul [2013] arguing that the cases of liver injury attributed to Herbalife products in the review article were too poorly documented to assign causality).
Patel SS, Beer S, Kearney DL, Phillips G, Carter BA. (2013). Green tea extract: a potential cause of acute liver failure. World J Gastroenterol. (16 year old boy developed jaundice 1-2 months after starting four HDS weight loss products including a GTE [bilirubin 14.8 mg/dL, ALT 2984 U/L, Alk P 186 U/L, INR 1.3], resolving within 3 months of stopping all four).
Navarro VJ, Bonkovsky HL, Hwang SI, Vega M, Barnhart H, Serrano J. (2013). Catechins in dietary supplements and hepatotoxicity. Dig Dis Sci. (Testing of 97 HDS products taken by 47 patients with suspected HDS related liver injury identified catechins in 50%, including 40% of those that were not labelled as containing catechins or GTE; concentrations varied widely [1 mcg to 486 mg/g] and did not correlate with severity or type of injury).
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. (2013). Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%], including 9 of 34 cases [27%] attributed to green tea, and that these other diagnoses weakened the causality assessment in most instances).
Licata A, Macaluso FS, Craxì A. (2013). Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med. (Review and commentary on herbal hepatotoxicity discusses pyrrolizidine alkaloids, green tea, Echinacea, kava, usnic acid, ephedra and products made by Herbalife, Hydroxycut and LipoKinetix).
Appelhans K, Najeeullah R, Frankos V. (2014). Considerations regarding the alleged association between Herbalife products and cases of hepatotoxicity. Intern Emerg Med. (Letter in response to Licata [2012] regarding the listing of Herbalife with other products implicated in causing liver injury, arguing that there are more than 100 Herbalife products which are mostly dietary supplements and foods, and no specific herbal has been identified in their products that might be a cause of liver injury).
Rossi S, Navarro VJ. (2014). Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol. (Review of current status of liver injury due to HDS including discussion of challenges of establishing causality and difficulties in identifying the potentially hepatotoxic components).
Teschke R, Frenzel C, Schulze J, Schwarzenboeck A, Eickhoff A. (2013). Herbalife hepatotoxicity: Evaluation of cases with positive reexposure tests. World J Hepatol. (Analysis of the published literature of outcome of rechallenge after suspected Herbalife hepatotoxicity identified 53 cases, 8 of which mentioned a positive rechallenge, however, documentation of the timing and results of rechallenge was frequently missing and only one case was suitably documented to judge the rechallenge using the RUCAM causality method).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury discusses the possible hepatotoxicity of green tea and the issue of whether green tea is protective against liver injury).
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. (2013). Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%], and that these other diagnoses weakened the causality assessment in most instances including 9 of the 34 cases [26%] attributed to green tea).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, two of which listed green tea as a component).
Licata A, Macaluso FS, Craxì A. (2013). Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med. (Review and commentary on herbal hepatotoxicity discusses Camellia sinensis as implicated in a total of 58 case reports, presenting as either acute hepatocellular or cholestatic hepatitis).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions that green tea is used as a weight loss agent and has been linked to cases of hepatitis, some with recurrence on re-exposure and some fatal).
Dağ MS, Aydınlı M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. (2014). Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol. (Between 2008 and 2012, 82 patients with drug or herbal supplement induced liver injury were seen at a single referral center in Turkey, 10 [12%] of which were due to HDS products, including 7 due to Teucrium polium [mountain germander] and 3 to GTE).
Teschke R, Genthner A, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2014). Herbal hepatotoxicity: Analysis of cases with initially reported positive re-exposure tests. Dig Liver Dis. (Reanalysis of 34 published cases of liver injury due to herbal medications in which there was a reported positive rechallenge, finding only 21 [62%] fulfilled the criteria of a positive rechallenge using RUCAM, the others having inconsistent [18%] or incomplete data [21%]; among 7 cases attributed to green tea, 3 rechallenges were considered uninterpretable).
Whitsett M, Marzio DH, Rossi S. (2014). SlimQuick™-associated hepatotoxicity resulting in fulminant liver failure and orthotopic liver transplantation. ACG Case Rep J. (52 year old woman developed jaundice 3 weeks after drinking Slimquick for 2 days [bilirubin 16.5 mg/dL, ALT 945 U/L, Alk P 210 U/L, ANA negative, INR 2.82], with progressive hepatic failure necessitating urgent liver transplant).
de Oliveira AV, Rocha FT, Abreu SR. (2014). Acute liver failure and self-medication. Arq Bras Cir Dig. (Review of published literature on acute liver failure associated with self-medication identified cases related to acetaminophen, GTE, linoleic acid, rhamnus purshianus [Fitosoja] and usnic acid).
Emoto Y, Yoshizawa K, Kinoshita Y, Yuki M, Yuri T, Yoshikawa Y, Sayama K, Tsubura A. (2014). Green tea extract-induced acute hepatotoxicity in rats. J Toxicol Pathol. (A single injection of GTE [200 mg/kg] in rats caused acute hepatic injury and fatalities, the rate of which varied by sex and age).
Teschke R, Zhang L, Melzer L, Schulze J, Eickhoff A. (2014). Green tea extract and the risk of drug-induced liver injury. Expert Opin Drug Metab Toxicol. (Review of literature on whether green tea intake might increase the risk of liver injury from other drugs, via drug-herb interactions, concludes that there is no evidence that it does).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, the single most commonly implicated herbal agent was green tea extract).
Rossi S, Navarro VJ. (2014). Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and assessing causality; does not discuss germander).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment, mentions that germander has been linked to more than 50 cases of hepatotoxicity presenting as acute or chronic hepatitis, cirrhosis or acute liver failure with massive necrosis).
Korth C. (2014). Drug-induced hepatotoxicity of select herbal therapies. J Pharm Pract. (Review of liver injury due to selected HDS discusses the literature implicating kava, GTE, germander, pyrrolizidine alkaloids and Herbalife products).
Mazzanti G, Di Sotto A, Vitalone A. (2015). Hepatotoxicity of green tea: an update. Arch Toxicol. (Updated review on the hepatotoxicity of green tea identified 19 published cases since their previous review [Massanti 2009], mostly in women [84%], hepatocellular in pattern [86%], 4 cases requiring liver transplantation, onset after variable period [2 days to 1 year], often given as a multiingredient supplement, largely for weight loss).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that there have been numerous reports of liver injury from GTE).
Stickel F, Shouval D. (2015). Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. (Extensive review of liver injury due to HDS mentions that GTE is a well established cause of liver injury).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being GTE).
Zheng EX, Navarro VJ. (2015). Liver injury from herbal, dietary, and weight loss supplements: a review. J Clin Transl Hepatol. (Review of literature on liver injury due to HDS products used for weight loss, focusing upon the case series of liver injury attributed to GTE as well as the commercial products that appear to contain it such as Herbalife and Hydroxycut, the injury of which was predominantly hepatocellular (acute hepatitis-like) and had a significant mortality rate).
Lugg ST, Braganza Menezes D, Gompertz S. (2015). Chinese green tea and acute hepatitis: a rare yet recurring theme. BMJ Case Rep. (16 year old girl developed jaundice 3 months after starting Chinese green tea, 3 cups daily [bilirubin 11.6 mg/dL, ALT 4371 U/L, Alk P 84 U/L, INR 1.9], resolving within 2 months of stopping).
Dostal AM, Samavat H, Bedell S, Torkelson C, Wang R, Swenson K, Le C, et al. (2015). The safety of green tea extract supplementation in postmenopausal women at risk for breast cancer: results of the Minnesota Green Tea Trial. Food Chem Toxicol. (Among 1075 postmenopausal women with high risk for breast cancer treated with green tea extract [1315 mg total catechins] or placebo for 12 months, ALT elevations arose in 6.7% of GTE vs 0.7% of controls and were above 5 times ULN in 1.3% vs 0%, but none were associated with symptoms or jaundice and all resolved rapidly with stopping therapy, but then recurred in 12 subjects who restarted GTE).
Kumar NB, Pow-Sang J, Spiess PE, Park J, Salup R, Williams CR, et al. (2016). Randomized, placebo-controlled trial evaluating the safety of one-year administration of green tea catechins. Oncotarget. (Among 97 men at risk for prostate cancer treated with GTE [400 mg EGCG] or placebo daily for 1 year, ALT elevations were common in both groups; no details provided).
Reddy S, Mishra P, Qureshi S, Nair S, Straker T. (2016). Hepatotoxicity due to red bush tea consumption: a case report. J Clin Anesth. (37 year old man who drank 10 cups of rooibos tea daily was found to have thrombocytopenia [42,000/µL] and abnormal liver tests when admitted for appendectomy [bilirubin 0.4 mg/dL, ALT 185 U/L, AST 606 U/L, Alk P 86 U/L], abnormalities resolving over the next week).
Couturier FJ, Colemont LJ, Fierens H, Verhoeven VM. (2016). Toxic hepatitis due to a food supplement: "natural" is no synonym for "harmless". Clin Res Hepatol Gastroenterol. (77 year old woman developed jaundice a month after starting a supplement containing red yeast rice and GTE [bilirubin 4.9 mg/dL, ALT 1742 U/L, Alk P 198 U/L], with complete recovery within 4 months of stopping).
Gedela M, Potu KC, Gali VL, Alyamany K, Jha LK. (2016). A case of hepatotoxicity related to Kombucha tea consumption. S D Med. (58 year old woman developed pain and itching followed by jaundice one month after starting daily Kombucha tea ingestion [bilirubin 4.1 mg/dL, ALT 330 U/L, Alk P 630 U/L], which fell to normal within a month of stopping).
Smith RJ, Bertilone C, Robertson AG. (2016). Fulminant liver failure and transplantation after use of dietary supplements. Med J Aust. (26 year old man developed jaundice 10 weeks after taking a weight loss supplement containing Garcinia cambogia [bilirubin 10.2 mg/dL, ALT 1520 U/L, Alk P 156 U/L, INR 1.3], with subsequent deterioration and liver transplant 2 months later).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products including green tea).
Avigan MI, Mozersky RP, Seeff LB. (2016). Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci. (Overview of the US regulations regarding herbal and dietary supplements and role of FDA, Department of Agriculture, Federal Trade Commission and Office of Dietary Supplements of the NIH in assessment of safety of HDS products including actions taken against Hydroxycut, Lipokinetix and OxyELITE Pro when reports of liver injury appeared in postmarketing phase).
Marcus DM. (2016). Dietary supplements: What's in a name? What's in the bottle?. Drug Test Anal. (Commentary on regulation of HDS products concludes: "the marketing of botanical supplements is based on unfounded claims that they are safe and effective", and "there is no reason to take herbal medicines whose composition and benefits are unknown and whose risks are evident").
Zheng EX, Rossi S, Fontana RJ, Vuppalanchi R, Hoofnagle JH, Khan I, Navarro VJ. (2016). Risk of liver injury associated with green tea extract in SLIMQUICK(®) weight loss products: results from the DILIN prospective study. Drug Saf. (Among 899 cases enrolled in a prospective US registry of drug induced liver injury between 2004 and 2013, 6 were attributed to SlimQuick, an over-the-counter product sold as a weight loss agent which contains GTE [initial bilirubin 0.4 to 40.5 mg/dL, ALT 446 to 1732 U/L, Alk P 81-239 U/L], one requiring an urgent liver transplant, but other 5 resolving spontaneously).
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists at least 46 published cases of green tea associated liver injury and concludes that green tea may warrant a warning label).
Wong LL, Lacar L, Roytman M, Orloff SL. (2017). Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products).
de Boer YS, Sherker AH. (2017). Herbal and dietary supplement-induced liver injury. Clin Liver Dis. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, pyrrolizidine alkaloids and proprietary multiingredient nutrition supplements [MINS]).
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al., Drug Induced Liver Injury Network (DILIN). (2017). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none specifically listing green tea as a component).
Kesavarapu K, Kang M, Shin JJ, Rothstein K. (2017). Yogi Detox Tea: a potential cause of acute liver failure. Case Rep Gastrointest Med. (60 year old woman developed jaundice after using "Yogi Detox Tea" 3 times daily for 14 days [bilirubin 27 mg/dL, ALT 583 U/L, Alk P 202 U/L, INR 4.0], dying 17 days after onset; the label listing 18 herbs including skullcap, rhubarb root and gardenia, but not Camellia sinensis).
Yu Z, Samavat H, Dostal AM, Wang R, Torkelson CJ, Yang CS, Butler LM, et al. (2017). Effect of green tea supplements on liver enzyme elevation: results from a randomized intervention study in the United States. Cancer Prev Res (Phila). (Among 1021 postmenopausal women treated with GTE or placebo for 12 months [Dostal 2015], 17 on GTE [3.6%] but none on placebo developed ALT elevations above 150 U/L, which returned to normal on stopping and increased again on restarting GTE, none developing clinically apparent liver injury but 36 were withdrawn for ALT levels above 90 U/L).
Dinakaran D, Bristow E, Armanious H, Garros D, Yap J, Noga M, Sergi C. (2017). Co-ingestion of willow bark tea and acetaminophen associated with fatal infantile fulminant liver failure. Pediatr Int. (28 month old boy developed agitation followed by coma 3 days after taking acetaminophen and "Lake Twig tea" which contains salicylates for a respiratory infection [bilirubin 3.0 mg/dL, ALT 7240 U/L, Alk P 372 U/L, INR 9.1, ammonia 619 µmol/L, pH 7.30, lactate 13 mmol/L], dying in coma with brain herniation 15 hours later; autopsy showing hepatomegaly, microvesicular steatosis and centrilobular necrosis consistent with Reye syndrome).
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. (2017). Liver injury from herbal and dietary supplements. Hepatology. (Review of the problems of liver injury and HDS products, specifically discusses GTE hepatotoxicity, the cause of which is unknown, although high doses are hepatotoxic in mice and more than 50 cases of clinically apparent liver injury have been attributed to its use, GTE being identified in almost half of HDS products implicated in liver injury, some of which were not labelled as containing GTE).
Gavrić A, Ribnikar M, Šmid L, Luzar B, Štabuc B. (2018). Fat burner-induced acute liver injury: Case series of four patients. Nutrition. (4 cases of clinically apparent liver injury from weight loss products advertised as “fat burners”, all women, ages 51 to 57 years, taking the products for 3-10 weeks, and presenting with jaundice [bilirubin 2.8 to 11.6 mg/dL, ALT 666-12,882 U/L, Alk P 162 to 242 U/L], one dying of liver failure and one with recurrence 5 years later after taking another fat burner, most products containing GTE, but others with spirulina, green coffee and roseslip).
Roytman MM, Poerzgen P, Navarro V. (2018). Botanicals and hepatotoxicity. Clin Pharmacol Ther. (Review of the hepatotoxicity and clinical features of injury caused by botanical agents including green tea, OxyELITE Pro and anabolic steroids).
Teschke R, Wolff A, Eickhoff A, Danan G. (2018). Is obesity rather than the dietary supplement used for weight reduction the cause of liver injury?. JGH Open. (Review of the literature on liver injury attributed to green tea suggested that nonalcoholic fatty liver might have been a contributing factor in cases in which green tea extract was being used as a weight loss agent).
Surapaneni BK, Le M, Jakobovits J, Vinayek R, Dutta S. (2018). A case of acute severe hepatotoxicity and mild constriction of common bile duct associated with ingestion of green tea extract: a clinical challenge. Clin Med Insights Gastroenterol. (50 year old woman developed fatigue and jaundice one month after starting dietary supplements containing green tea extract [bilirubin 38 mg/dL, ALT 1170 U/L, Alk P 113 U/L], initially managed with ERCP, biliary stenting and corticosteroids, resolving over the next 6 weeks).
EFSA Panel on Food Additives and Nutrient Sources added to Food (ANS), Younes M, Aggett P, Aguilar F, Crebelli R, Dusemund B, Filipič M, Frutos MJ, et al. Scientific opinion on the safety of green tea catechins. EFSA J 2018; 16: e05239. (Review of the literature by an expert panel concluded that green tea infusions and drinks should be considered “generally as safe” although there are rare instances of associated liver injury which are probably idiosyncratic reactions, but that doses of green tea extracts equivalent to 800 mg of EGCG or more daily can be associated with significant aminotransferase elevations).
D'Agostinoa D, Cavalieri ML, Arcucci MS. (2019). Hepatitis grave producida por intoxicación con té verde en un niño. Presentación de un caso. Arch Argent Pediatr. (2 year old child on daily green tea ingestion because of milk allergy developed acute liver injury [bilirubin 2.5 mg/dL, ALT 1500 U/L, Alk P 482 U/L, INR 1.0], enzymes returning to normal within 2 months of stopping).
Lin K, Lin AN, Linn S, Hlaing PP, Vasudevan V, Reddy M. (2018). Ginseng-related drug-induced liver injury. Case Rep Gastroenterol. (45 year old Chinese-American woman developed abdominal pain and nausea 3 months after starting ginseng for menopausal symptoms [bilirubin 5.0 mg/dL, ALT 343 U/L, Alk P 182 U/L, INR 1.2], resolving within 2 months of stopping).
Benesic A, Gerbes AL. (2018). Herbal tea and liver injury – tea extract or comedication can make a difference. J Hepatol. (Two patients with suspected green tea related liver injury tested positive in an in vitro assay using the patients’ own monocyte-transformed hepatocyte-like cells exposed to EGCG).
Rodriguez EA, Teixeira Yokoda R, Payton DE, Pai R, Byrne TJ. (2019). Acute hepatitis secondary to the use of "Ilex paraguariensis" (Mate Tea): a case report and Review of Literature. Case Reports Hepatol. (21 year old man developed fatigue and jaundice after spending 4 months in Argentina where he drank Yerba Mate tea on a regular basis [bilirubin 32.9 mg/dL, ALT 2684 U/L, Alk P 129 U/L, INR 1.2], resolving within 6-8 weeks of onset).
Ruperti-Repilado FJ, Haefliger S, Rehm S, Zweier M, Rentsch KM, Blum J, Jetter A, et al. (2019). Danger of herbal tea: a case of acute cholestatic hepatitis due to "Artemisia annua" tea. Front Med (Lausanne). (51 year old man developed fatigue followed by jaundice shortly after finishing a 4 week course of Artemisia annua powder tea while traveling to Ethiopia [bilirubin 11.0 mg/dL, ALT 91 U/L, Alk P 151 U/L], with prolonged jaundice but ultimately resolving).
Hadjipanayis A, Efstathiou E, Papaevangelou V. (2019). Hepatotoxicity in an adolescent with black iced tea overconsumption. Pediatr Gastroenterol Hepatol Nutr. (12 year old boy developed fatigue and itching having consumed 1.5-2.0 liters of iced black tea daily for 3 months [bilirubin 3.0 mg/dL, ALT 427 U/L, Alk P 910 U/L, GGT 182 U/L], the abnormalities resolving within 2 months of stopping the black tea).
Oketch-Rabah HA, Roe AL, Rider CV, Bonkovsky HL, Giancaspro GI, Navarro V, Paine MF, et al. (2020). United States Pharmacopeia (USP) comprehensive review of the hepatotoxicity of green tea extracts. Toxicol Rep. (An extensive review of the chemistry and potential toxicity of green tea concluded that green tea was a rare cause of liver injury and that it should be labeled with a warning).
Hoofnagle JH, Bonkovsky HL, Phillips EJ, Li YJ, Ahmad J, Barnhart H, Durazo F, et al., Drug-Induced Liver Injury Network. (2020). HLA-B*35:01 and green tea induced liver injury. Hepatology. (Among 1414 cases of drug induced liver injury enrolled in a prospective US database between 2004 and 2018, 1142 were attributed to conventional drugs and 273 to HDS, of which 40 were judged to be due to green tea, often as a part of a multiingredient product, with a median latency of 42 days and hepatocellular injury [95%] which was severe in 35% and led to liver transplantation in 8%; 3 patients had documented recurrence upon reexposure; HLA-B*35:01 was present in 72% of green tea cases versus 11-15% of controls suggesting an immunologic pathogenesis).

## OTHER REFERENCE LINKS

1 Recent References on Green Tea: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(green+tea)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Green Tea: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=green+tea)